# Bromocriptine

## OVERVIEW

### Introduction

Bromocriptine is an oral dopamine receptor agonist used predominantly in the therapy of Parkinson disease, but which has other activities including inhibition of prolactin and growth hormone release which has led to its use in acromegaly, infertility and galactorrhea. Bromocriptine therapy is associated with low rate of transient serum enzyme elevations during treatment and has been implicated in rare cases of acute liver injury.

### Background

Bromocriptine (broe" moe krip' teen) is a semisynthetic ergot alkaloid derivative which acts as a dopamine receptor agonist. Bromocriptine has strong agonist activity on the D2 class of dopamine receptors and partial antagonist of the D1 receptors in central nervous system. Bromocriptine was approved for use in the United States in 1978, the first in this class of agents, and has been in wide use since. Current indications are the therapy of symptomatic Parkinson disease as well as spastic disorders and extrapyramidal disorders caused by medications. Bromocriptine also has inhibitory activity on prolactin and growth hormone release, and its indications also include treatment of amenorrhea and galactorrhea related to hyperprolactinemia, female infertility, acromegaly, Cushing syndrome and premenstrual syndrome. Bromocriptine is available in tablets of 2.5 mg and capsules of 5 mg in generic forms and under the brand name of Parlodel. The recommended dose for Parkinson disease is 10 to 40 mg daily, but it must be introduced gradually and the dose titrated based upon tolerance and effect. In Parkinson disease, it is usually used in combination with levodopa/carbidopa. Common side effects include profound hypotension (with the first dose), somnolence, fatigue, vivid dreams, anxiety, confusion, hallucinations, delusions, depression, dizziness, headache, nausea and gastrointestinal upset, symptoms common with increased dopaminergic activity.

### Hepatotoxicity

Bromocriptine has been reported to cause serum aminotransferase elevations in a small proportion of patients, but these abnormalities are usually mild, asymptomatic and self-limiting even without dose adjustment. In rare instances, more marked elevations occur that may require dose modification or discontinuation and which can recur with rechallenge. In addition, bromocriptine has been implicated in a small number of cases of clinically apparent acute liver injury, but the clinical characteristics and typical pattern of enzyme elevations has not been characterized and case reports of hepatic injury due to bromocriptine have not been published. Thus, bromocriptine is a very rare cause of clinically apparent liver injury and has not been implicated in causing acute liver failure or chronic liver injury.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Bromocriptine is rapidly removed from the serum by the liver with extensive first pass metabolism. Bromocriptine is metabolized to inactive forms largely by hydrolysis and excreted rapidly.

### Outcome and Management

Most instances of suspected hepatotoxicity of bromocriptine have been mild and self-limited. There have been no reports of acute liver failure or chronic hepatitis due to bromocriptine. There is likely cross sensitivity to hypersensitivity reactions among the different ergot alkaloids, such as pergolide.

Drug Class: Antiparkinson Agents

Other Drugs in the Subclass, Dopamine Receptor Agonists: Apomorphine, Pergolide, Pramipexole, Ropinirole, Rotigotine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bromocriptine – Generic, Parlodel®

DRUG CLASS

Antiparkinson Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bromocriptine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bromocriptine | 25614-03-3 | C32-H40-Br-N5-O5 | Bromocriptine Chemical Structure

## REFERENCES

References updated: 20 July 2017

Zimmerman HJ. Antiparkinsonism drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 715-7. (Expert review of hepatotoxicity published in 1999; among anticholinergic agents, "only trihexyphenidyl has been incriminated in hepatic injury"; other antiparkinsonism drugs discussed include levodopa, lergotrile [no longer available], pergolide and bromocriptine).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier Inc, 2013, pp. 443-62. (Review of hepatotoxicity of agents acting on the central nervous system).
Standaert DG, Roberson ED. Treatment of central nervous system degenerative disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 609-28. (Textbook of pharmacology and therapeutics).
McDowell F. Symposium on levodopa in Parkinson's disease. Clinical and pharmacological aspects. Clinical laboratory abnormalities. Clin Pharmacol Ther 1971; 12: 335-9. (Retrospective analysis of laboratory abnormalities arising in 974 patients with Parkinson disease treated with levodopa; AST elevations occurred in 9% of 5427 determinations, but were usually mild and transient returning to normal in 1-2 months without dose adjustment; AST levels rose to 1600 U/L in one patient who later died of complications of diabetes). 4102803
Calne DB, Plotkin C, Williams AC, Nutt JG, Neophytides A, Teychenne PF. Long-term treatment of parkinsonism with bromocriptine. Lancet 1978; 1: 735-8. (Retrospective analysis of experience in treating 92 patients with Parkinson disease using bromocriptine and levodopa for up to 30 months, serum enzyme elevations occurred in 6 patients [7%] which were transient in 4, required dose modification in 1 and stopping in 1; no clinically apparent liver injury). 76747
Lieberman AN, Kupersmith M, Gopinathan G, Estey E, Goodgold A, Goldstein M. Bromocriptine in Parkinson disease: further studies. Neurology 1979; 29: 363-9. (Retrospective analysis of experience in treating 66 patients with Parkinson disease using bromocriptine for 2-24 months; mild Alk P elevations occurred in 22% and one patient developed jaundice after 2 months, biopsy showing a toxic hepatitis and stopping leading to recovery; no details given). 571981
LeWitt PA, Ward CD, Larsen TA, Raphaelson MI, Newman RP, Foster N, Dambrosia JM, et al. Comparison of pergolide and bromocriptine therapy in parkinsonism. Neurology 1983; 33: 1009-14. (27 patients with Parkinson disease were treated with either pergolide or bromocriptine in a double-blind cross over study and 11 were continued on pergolide for up to one year; the two drugs had comparable effects and side effects, one patient developed mild ALT elevations [59 U/L] that resolved despite continuing bromocriptine). 6348585
Lieberman AN, Gopinathan G, Neophytides A, Goldstein M. Management of levodopa failures: the use of dopamine agonists. Clin Neuropharmacol 1986; 9: S9-21. (Among 278 patients with Parkinson disease failing to respond to levodopa and treated with a dopamine agonist, 61% improved but adverse events requiring discontinuation occurred in 46%; no discussion of hepatotoxicity). 3297319
Liberato NL, Poli M, Bollati P, Chiofalo F, Filipponi M. Bromocriptine-induced acute hepatitis. Lancet 1992; 340: 969-70. (82 year old man with Parkinson disease developed ALT elevations [peak value ~730 U/L] within 5 days of starting bromocriptine, resolving within 10 days of stopping and recurring [peak value ~750 U/L] within 5 days of restarting; no mention of symptoms or bilirubin levels). 1357362
Korczyn AD, Brunt ER, Larsen JP, Nagy Z, Poewe WH, Ruggieri S. A 3-year randomized trial of ropinirole and bromocriptine in early Parkinson's disease. The 053 Study Group. Neurology 1999; 53: 364-70. (In a randomized controlled trial in 35 patients with early Parkinson disease comparing ropinirole to bromocriptine, "no significant laboratory abnormalities" or withdrawals because of liver abnormalities were reported). 10430427
Lambert D, Waters CH. Comparative tolerability of the newer generation antiparkinsonian agents. Drugs Aging 2000; 16: 55-65. (Review of mechanism of action, tolerability and safety of selegiline, pramipexole, ropinirole, tolcapone and entacapone in Parkinson disease). 10733264
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to agents used for Parkinson disease). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25,1425. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to an agent used to treat Parkinson disease). 23419359
Drugs for Parkinson's disease. Treat Guidel Med Lett 2013; 11 (135): 101-6. (Concise review of recommendations for therapy of Parkinson disease with description of mechanisms of action, efficacy and adverse events). 24165688
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an agent to treat Parkinson disease). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, none were attributed to an agent used to treat Parkinson disease). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Bromocriptine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Bromocriptine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bromocriptine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bromocriptine)